# Tezepelumab

## OVERVIEW

### Introduction

Tezepelumab is a human monoclonal antibody to thymic stromal lymphopoietin which is used as an add-on maintenance treatment of patients aged 12 years and older with severe uncontrolled asthma. Tezepelumab is generally well tolerated and has not been linked to serum aminotransferase elevations during therapy or to instances of clinically apparent liver injury.

### Background

Tezepelumab (tez” e pel’ ue mab) is a human monoclonal IgG2 antibody directed against thymic stromal lymphopoietin (TSLP), an epithelial cell cytokine produced and secreted in response to allergens, pollutants and viruses that initiates a release of inflammatory cytokines. Thymic stromal lymphopoietin is found in high levels in patients with asthma and correlates with disease severity. Inhibition of the cytokine results in a decrease in release of inflammatory cytokines and subsequent bronchoconstriction. Tezepelumab has been evaluated in several randomized controlled trials in patients with severe, uncontrolled asthma and found to decrease asthma exacerbations and improve pulmonary function tests that are typically worsened by bronchoconstriction, such as the forced expiratory volume (FEV_1_). In 2021, tezepelumab was approved as add-on maintenance therapy for severe asthma in adults and children aged 12 years or above. It is available in single dose prefilled syringes and in vials of 210 mg in 1.91 mL under the brand name Tezspire. The recommended dose is 210 mg given subcutaneously once every 4 weeks. While generally well tolerated, side effects can include pharyngitis, and joint and back pain. Rare but potentially severe adverse events include hypersensitivity reactions (rash, allergic conjunctivitis) and worsening of parasitic infections, which should be treated before initiating tezepelumab therapy.

### Hepatotoxicity

In multiple preregistration trials of tezepelumab as therapy of severe, uncontrolled asthma, there was no mention of elevations of ALT levels or of cases of acute liver injury or jaundice. Since its approval and more general use, tezepelumab has not been linked to instances of clinically apparent liver injury with jaundice.

Likelihood score: E (unlikely cause of clinically apparent acute liver injury).

### Mechanism of Injury

The possible mechanisms of liver injury due to tezepelumab are unclear. Monoclonal antibodies and immunoglobulins are generally taken up and metabolized intracellularly to short peptides and amino acids. There is no evidence to suggest that inhibition of thymic stromal lymphopoietin would trigger liver injury or autoimmune liver conditions.

Drug Class: Antiasthmatic Agents, Monoclonal Antibodies

Other Drugs in the Subclass, Antiasthmatic Agents, Monoclonal Antibodies: Dupilumab, Mepolizumab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Tezepelumab – Tezspire®

DRUG CLASS

Antiasthmatic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Tezepelumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Tezepelumab | 1572943-04-4 (https://pubchem.ncbi.nlm.nih.gov/substance/381127637) | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 27 January 2023

Abbreviations used: FEV_1_, forced expiratory volume in 1 second.

FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2022/761224Orig1s000MultidisciplineR.pdf (Multidisciplinary FDA review of tezepelumab in support of its approval for use in severe asthma does not mention hepatotoxicity or ALT elevations and there were no hepatobiliary deaths or treatment related severe adverse events in preregistration clinical trials).
Corren J, Parnes JR, Wang L, Mo M, Roseti SL, Griffiths JM, van der Merwe R. (2017). Tezepelumab in adults with uncontrolled asthma. N Engl J Med. (Among 550 patients with uncontrolled moderate-to-severe asthma treated with tezepelumab [70, 210 or 280 mg] or placebo given subcutaneously at 2 to 4 week intervals, exacerbation rates were decreased and FEV_1_ increased with all 3 dose regimens compared to placebo, while both total and severe adverse event rates were similar in all groups, and there were no hepatic severe adverse events; no mention of ALT elevations).
Menzies-Gow A, Corren J, Bourdin A, Chupp G, Israel E, Wechsler ME, Brightling CE, et al. (2021). Tezepelumab in adults and adolescents with severe, uncontrolled asthma. N Engl J Med. (Among 1061 patients [ages 12 to 80 years] with severe, uncontrolled asthma treated with tezepelumab [210 mg] or placebo subcutaneously every 4 weeks for 52 weeks, asthma exacerbations were reduced by more than 50% with tezepelumab while FEV_1_ improved, and total and severe adverse event rates were similar in the two groups and there were no liver related severe adverse events; no mention of ALT levels or hepatotoxicity).
(2022). Tezepelumab (Tezspire) for severe asthma. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, safety and costs of tezepelumab shortly after its approval in the US does not mention hepatotoxicity or ALT elevations).
Wechsler ME, Menzies-Gow A, Brightling CE, Kuna P, Korn S, Welte T, Griffiths JM, et al., SOURCE study group. (2022). Evaluation of the oral corticosteroid-sparing effect of tezepelumab in adults with oral corticosteroid-dependent asthma (SOURCE): a randomised, placebo-controlled, phase 3 study. Lancet Respir Med. (Among 150 adults with asthma and inadequate control despite receiving medium- or high-dose corticosteroids who were treated with either tezepelumab [210 mg] or placebo subcutaneously every 4 weeks for 48 weeks, there was no difference in the reduction in oral corticosteroid use between the two groups and both total and adverse event rates were similar in the two groups; no mention of ALT elevations or hepatotoxicity).
Menzies-Gow A, Wechsler ME, Brightling CE, Korn S, Corren J, Israel E, Chupp G, et al.; DESTINATION study investigators. Long-term safety and efficacy of tezepelumab in people with severe, uncontrolled asthma (DESTINATION): a randomised, placebo-controlled extension study. Lancet Respir Med. 2023:S2213-2600(22)00492-1. Epub ahead of print. (Among patients with asthma enrolled in two placebo controlled trials of tezepelumab for severe, uncontrolled asthma who were crossed over to or continued on drug for another 48 weeks, adverse events were less during the second than the first 48 weeks of therapy or placebo; no mention of hepatotoxicity or ALT elevations).

## OTHER REFERENCE LINKS

1 Recent References on Tezepelumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Tezepelumab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Tezepelumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Tezepelumab)